# Ensartinib

## OVERVIEW

### Introduction

Ensartinib is a small molecule inhibitor of anaplastic lymphoma kinase (ALK) and is used to treat adults with locally advanced or metastatic non-small cell lung cancer. Ensartinib is associated with transient elevations in serum aminotransferase levels and bilirubin during therapy and rare instances of drug induced liver injury.

### Background

Ensartinib (en sar’ tin ib) is an orally available, specific inhibitor of anaplastic lymphoma kinase (ALK) that is used in the therapy of advanced or metastatic non-small cell lung cancer (NSCLC). The mutated, rearranged ALK is found in 5% of cases of NSCLC and promotes unregulated cell growth and proliferation by the cancer cells. Ensartinib has activity against many of the mutated forms of ALK as well as several other kinases that are found mutated in NSCLC such as MET (mesenchymal epithelial transition factor) and ROS1 (a tyrosine kinase proto-oncogene). In cell lines, ensartinib blocked ALK-mediated signaling pathways and inhibited proliferation of cells harboring ALK fusions and mutations that were resistant to other ALK inhibitors. Ensartinib also demonstrated antitumor activity in animal xenograft models of human ALK positive NSCLC. In a large, controlled trial, ensartinib was compared to crizotinib (a first generation ALK inhibitor) in 28 day cycles in patients with advanced or metastatic NSCLC with an ALK rearrangement. The median progression-free survival was superior with ensartinib (25.8 months) compared to crizotinib (12.7 months). Ensartinib was approved as treatment for patients with locally advanced or metastatic NSCLC in the United States in 2024, the sixth ALK-inhibitor approved for therapy of NSCLC, after crizotinib (2011), alectinib (2015), brigatinib (2017), ceritinib (2017), or lorlatinib (2018). Ensartinib is available in capsules of 25 and 100 mg under the brand name Ensacove. The recommended dose is 225 mg once daily until unacceptable toxicity or disease progression arises. Side effects are common and include mild-to-moderate rash, musculoskeletal pain, constipation, pruritus, cough, nausea, edema, fatigue, and pyrexia. Laboratory abnormalities can include increases in uric acid, magnesium, amylase, ALT, AST, GGT, bilirubin, and CPK, as well as decreases in lymphocytes, hemoglobin, phosphate, potassium, and sodium. Less frequent but potentially severe adverse events include interstitial lung disease, pneumonitis, hepatotoxicity, severe skin rash, bradycardia, visual disturbances, hyperglycemia, hyperuricemia, increased CPK, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure trials of ensartinib as therapy of NSCLC, liver test abnormalities were frequent, with elevations in ALT levels in 59%, AST in 58%, Alk P in 51%, and bilirubin in 12% of treated participants. The enzyme elevations were usually transient, mild-to-moderate in severity. Pruritus was seen in 26%. ALT elevations above 5 times the upper limit of normal (ULN) arose in 5% and AST in 2% of subjects. The average time to onset of increased aminotransferase levels was 5 weeks (range <1 to 152 weeks), leading to dose interruptions in 5% of patients but discontinuations in only 1%. One of the 143 patients receiving ensartinib in prelicensure studies was diagnosed with drug induced liver injury, but details were not provided and no patient with significant ALT elevations developed jaundice. Furthermore, there were no deaths or episodes of life-threatening liver injury. The product label for ensartinib recommends monitoring liver tests before and during therapy. Since approval and more widespread use of ensartinib, there have been no published case reports of clinically apparent liver injury with jaundice, but clinical experience with its use has been limited.

Likelihood score: D* (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from ensartinib therapy are probably the result of direct toxicity of the multi-kinase inhibition. Ensartinib is metabolized in the liver largely via the CYP 3A4 pathway, and liver injury might also be caused by production of a toxic or immunogenic intermediate of its metabolism. Because it is a substrate for CYP 3A4, ensartinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

The product label for ensartinib recommends monitoring of liver tests before initiating therapy and frequently during treatment, including every 2 weeks during the first cycle of therapy and monthly thereafter and as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to at least temporary cessation. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between ensartinib and other ALK inhibitors such as alectinib, brigatinib, lorlatinib, or ceritinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other ALK Targeted Inhibitors: Alectinib, Brigatinib, Ceritinib, Crizotinib, Lorlatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ensartinib – Ensacove®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ensartinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ensartinib | 1370651-20-9 | C26-H27-Cl2-FN6-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 31 March 2025

Abbreviations: NSCLC, non-small cell lung cancer; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as ensartinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not ensartinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/218171Orig1s000IntegratedR.pdf (FDA review of the data on efficacy and safety of ensartinib in support of its approval for NSCLC in the US, mentions that liver test abnormalities were frequent in the 458 patients who received ensartinib, ALT elevations arising in 59%, AST in 58%, Alk P in 51%, and bilirubin in 12%; ALT values rose above 5 times the upper limit of normal (ULN) in 5% of patients and aminotransferase elevations led to dose interruptions in 4.6% and discontinuation in 1.3%, with one instance of suspect drug-induced liver injury but no instances of life-threatening or fatal liver injury).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; ensartinib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of ensartinib which is not discussed). 23620168
Horn L, Infante JR, Reckamp KL, Blumenschein GR, Leal TA, Waqar SN, Gitlitz BJ, et al. Ensartinib (X-396) in ALK-positive non-small cell lung cancer: Results from a first-in-human phase I/II, multicenter study. Clin Cancer Res. 2018;24:2771-2779. (In an open label dose-finding study of ensartinib for advanced, ALK-positive NSCLC, a dose of 225 mg daily was chosen as optimal and subsequently yielded an objective response rate of 60% and acceptable toxicity, including AST elevations in 12% which were above 5 times ULN in only 1% of participants). 29563138
Yang Y, Zhou J, Zhou J, Feng J, Zhuang W, Chen J, Zhao J, et al. Efficacy, safety, and biomarker analysis of ensartinib in crizotinib-resistant, ALK-positive non-small-cell lung cancer: a multicentre, phase 2 trial. Lancet Respir Med. 2020;8:45-53. (Among 160 adults with advanced, ALK-positive NSCLC with tumor progression after treatment with crizotinib, 52% had an objective response to ensartinib [including 70% of those with brain metastases] with elevations in ALT in 46% which were above 5 times ULN in 6%, but only 2 subjects required drug discontinuation because of liver test abnormalities, and none developed clinically apparent liver injury with jaundice). 31628085
Peng L, Xiao K, Cui J, Ye XH, Zhang YC, Mao L, Selvaggi Get al. Successful treatment with ensartinib after alectinib-induced hyperbilirubinemia in ALK-positive NSCLC. Onco Targets Ther. 2021;14:3409-3415. (56 year old Chinese man with NSCLC developed itching and jaundice 4 months after starting alectinib [bilirubin 18.4 mg/dL, ALT 42 U/L, Alk P 374 U/L], which slowly resolved after stopping and he was later treated with ensartinib with a tumor response and no worsening of bilirubin or liver enzymes). 34079286
Horn L, Wang Z, Wu G, Poddubskaya E, Mok T, Reck M, Wakelee H, et al. Ensartinib vs crizotinib for patients with anaplastic lymphoma kinase-positive non-small cell lung cancer: a randomized clinical trial. JAMA Oncol. 2021;7:1617-1625. (Among 290 patients with advanced ALK-positive NSCLC treated with ensartinib or crizotinib, progression-free survival was 25.8 vs 12.7 months, while adverse event rates were similar including serious events in 7.7% vs 6.1%, drug discontinuations in 9.1% vs 6.8%, the most common adverse events being rash [70% vs 10%] and ALT elevations [50% vs 47%] that were above 5 times ULN in 4.2% vs 7.5%, elevations in liver enzymes being the most frequent reason for drug discontinuation). 34473194
Ensartinib (Ensacove) for non-small cell lung cancer. Med Lett Drugs Ther. 2025;67:e34-e35. (Concise review of the mechanism of action, clinical efficacy, and safety of ensartinib shortly after its approval for use in the US, mentions hepatotoxicity as an adverse reaction without providing details). 39946703

## OTHER REFERENCE LINKS

1. Recent References on Ensartinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ensartinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ensartinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ensartinib)